# Dutasteride

## OVERVIEW

### Introduction

Dutasteride is a 5-alpha reductase inhibitor used in the therapy of symptomatic benign prostatic hypertrophy. Dutasteride is associated with a low rate of transient serum aminotransferase elevations, but has yet to be linked to instances of clinically apparent acute liver injury.

### Background

Dutasteride (doo tas' ter ide) was the second 5-alpha reductase inhibitor to be approved in the United States for the treatment of symptomatic benign prostatic hypertrophy. Dutasteride inhibits the conversion of testosterone to dihydrotestosterone, which is important in the development and maintenance of prostatic hyperplasia. Dihydrotesterone levels decrease during dutasteride therapy, but serum testosterone levels do not. Dutasteride usually takes several months to have an effect on prostate size and the symptoms of prostatic hypertrophy (urinary hesitancy and poor stream), unlike the alpha-1 adrenergic receptor blockers (alpha blockers) which have a more immediate effect. Dutasteride was approved for use in the United States in 2001 and is available in 0.5 mg capsules generically and under the trade name Avodart. A fixed dose combination of dutasteride (0.5 mg) with tamsulosin (0.4 mg: an alpha blocker) is available under the trade name Jalyn. The recommended dose of dutasteride is 0.5 mg once daily. Dutasteride is usually given long term and an effect is usually not seen until 3 to 6 months of therapy. Side effects are uncommon, but include impotence and decreased libido, ejaculation disorders, gynecomastia, dizziness and fatigue. Dutasteride also decreases serum PSA levels which should be monitored during therapy.

### Hepatotoxicity

Dutasteride has been associated with a low rate of serum aminotransferase elevations that, in controlled trials, was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. There have been no published reports of clinically apparent liver injury due to dutasteride therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations associated with dutasteride is not known. Dutasteride is an azosteroid and is extensively metabolized in the liver by the cytochrome P450 system (predominantly CYP 3A4 and 3A5).

References on the safety and potential hepatotoxicity of dutasteride are given in the Overview section on the 5-Alpha Reductase Inhibitors.

Drug Class: Benign Prostatic Hypertrophy Agents, 5-Alpha Reductase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dutasteride – Avodart®

DRUG CLASS

Benign Prostatic Hypertrophy Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dutasteride)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dutasteride | 164656-23-9 | C27-H30-F6-N2-O2 | Dutasteride Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Dutasteride: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Dutasteride/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Dutasteride: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dutasteride)